# Ixekizumab

## OVERVIEW

### Introduction

Ixekizumab is a humanized monoclonal antibody to interleukin-17A which acts as an antiinflammatory agent and is used to treat moderate-to-severe plaque psoriasis. Ixekizumab has not been linked to serum enzyme elevations during therapy or to instances of idiosyncratic acute liver injury.

### Background

Ixekizumab (ix" ee kiz' ue mab) is a recombinant, humanized IgG4 monoclonal antibody to interleukin (IL)-17A, an important cytokine responsible for local release of proinflammatory mediators. The binding of the monoclonal antibody to the cytokine blocks its interaction with the receptor and thus decreases inflammatory pathways that are involved in immune mediated cell injury. Ixekizumab is considered an immunomodulatory and antiinflammatory agent and has been evaluated in several immune mediated diseases including rheumatoid arthritis, Crohn disease and psoriasis. In large clinical trials in moderate-to-severe plaque psoriasis, ixekizumab was shown to be beneficial in reducing symptoms and signs of the disease. Ixekizumab was approved for this use in the United States in 2016 and was the second IL-17A antagonist approved for this indication, the other being secukinumab [2015]. Ixekizumab is available in solution for injection in single dose prefilled syringes and autoinjectors of 80 mg [in one mL] under the brand Taltz. The recommended dose is 160 mg subcutaneously initially and then 80 mg every 2 weeks for 12 weeks and every 4 weeks thereafter. Side effects are not common, but can include injection site reactions, nausea, headache, upper respiratory tract and tinea infections. Rare, but potentially severe adverse reactions include neutropenia, severe bacterial infections, reactivation of tuberculosis, exacerbation of inflammatory bowel disease and immediate hypersensitivity reactions.

### Hepatotoxicity

In large premarketing clinical trials, serum enzyme elevations were no more frequent with ixekizumab than with placebo injections and there were no instances of clinically apparent liver injury attributed to its use. Serum ALT elevations above 5 times the upper limit of normal were rare (<0.5%) and resolved without need of dose modification or discontinuation. Ixekizumab has had limited clinical use, but since its approval there have been no published case reports of liver injury attributed to ixekizumab therapy and no cases of reactivation of hepatitis B or autoimmune hepatitis, two possible hepatic complications of immunomodulatory monoclonal antibody therapy.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which ixekizumab might cause liver injury is unknown. Ixekizumab is a monoclonal antibody and, like other proteins, is metabolized into amino acids and is unlikely to have intrinsic toxicity. Because of its immunomodulatory activity, ixekizumab might induce an autoimmune reaction against hepatocytes, but this has not been shown.

Other immunomodulatory biologic agents used to treat severe psoriasis include adalimumab, brodalumab, certolizumab, efalizumab, etanercept, golimumab, infliximab, secukinumab and ustekinumab.

Drug Class: Dermatologic Agents, Psoriasis Agents; Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ixekizumab – Taltz®

DRUG CLASS

Dermatologic Agents, Psoriasis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ixekizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Ixekizumab | 1143503-69-8 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 25 May 2017

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; mentions rituximab and problems of reactivation of hepatitis B, but also states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; ixekizumab is not specifically mentioned).
Kensky AM, Vincenti F, Bennett WM. Immunomodulators. In, Brunton LL, Lazo JS, Parker KL, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 11th ed. New York: McGraw-Hill, 2006, pp. 1005-30. (Textbook of pharmacology and therapeutics).
Burkhart C, Morrell D, Goldsmith L. Biologic agents. Dermatological pharmacology. In, Brunton LL, Lazo JS, Parker KL, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 11th ed. New York: McGraw-Hill, 2006, pp. 1824-7. (Textbook of pharmacology and therapeutics).
Leonardi C, Matheson R, Zachariae C, Cameron G, Li L, Edson-Heredia E, Braun D, Banerjee S. Anti-interleukin-17 monoclonal antibody ixekizumab in chronic plaque psoriasis. N Engl J Med 2012; 366: 1190-9. (Among 142 patients with psoriasis treated with ixekizumab [10, 25, 75 or 150 mg] or placebo for 16 weeks, clinical response rates were above 75% at high doses of ixekizumab but only 8% with placebo, and there were no serious adverse events or deaths while mean values of ALT and bilirubin “showed no change from baseline”). 22455413
Gordon KB, Leonardi CL, Lebwohl M, Blauvelt A, Cameron GS, Braun D, Erickson J, et al. A 52-week, open-label study of the efficacy and safety of ixekizumab, an anti-interleukin-17A monoclonal antibody, in patients with chronic plaque psoriasis. J Am Acad Dermatol 2014; 71: 1176-82. (Among 120 patients with psoriasis enrolled in an open label extension study after a controlled trial [Leonardi 2012], clinical response rates increased and were maintained through 52 weeks; among 15 serious adverse events, none were liver-related and most were considered unrelated to therapy). 25242558
Langley RG, Elewski BE, Lebwohl M, Reich K, Griffiths CE, Papp K, Puig L, et al.; ERASURE Study Group; FIXTURE Study Group. Secukinumab in plaque psoriasis--results of two phase 3 trials. N Engl J Med 2014; 371: 326-38. (Among 1044 patients with plaque psoriasis treated with secukinumab [anti-IL-17A] or placebo in two large 52 week clinical trials, common side effects were nasopharyngitis, upper respiratory infection and diarrhea; no mention of ALT elevations or hepatotoxicity). 25007392
Genovese MC, Greenwald M, Cho CS, Berman A, Jin L, Cameron GS, Benichou O, et al. A phase II randomized study of subcutaneous ixekizumab, an anti-interleukin-17 monoclonal antibody, in rheumatoid arthritis patients who were naive to biologic agents or had an inadequate response to tumor necrosis factor inhibitors. Arthritis Rheumatol 2014; 66: 1693-704. (Among 348 patients with rheumatoid arthritis treated with ixekizumab [3, 10, 30, 80 or 180 mg] vs placebo for 12 weeks, clinical improvements were more frequent at the higher doses [39-54%] than with placebo [23-35%], while adverse event rates were similar; one patient on ixekizumab developed ALT elevations above 5 times ULN without bilirubin or Alk P elevations which resolved spontaneously without dose adjustment). 24623718
Griffiths CE, Reich K, Lebwohl M, van de Kerkhof P, Paul C, Menter A, Cameron GS, et al.; UNCOVER-2 and UNCOVER-3 investigators. Comparison of ixekizumab with etanercept or placebo in moderate-to-severe psoriasis (UNCOVER-2 and UNCOVER-3): results from two phase 3 randomised trials. Lancet 2015; 386 (9993): 541-51. (Among 2570 patients with plaque psoriasis treated with etanercept, placebo or ixekizumab for 12 weeks, clinical improvements were more frequent with ixekizumab [78-90%] than etanercept [42-53%] or placebo [2-7%] as were adverse events, including injection site reactions and headache while “overall, we noted no clinically important changes from baseline in mean liver biochemical test results… in any treatment group”). 26072109
Drugs for psoriasis. Med Lett Drugs Ther 2015; 57 (1470): 81-4. (Concise summary of current options for therapy of psoriasis including topical agents, phototherapy, oral systemic drugs, and biologic agents including secukinumab [anti-IL-17A], but not brodalumab [anti-IL-17A receptor] or ixekizumab [anti-IL-17A]; mentions that serious infections occurred in 1.2% of secukinumab treated patients; no mention of hepatotoxicity). 26035749
Genovese MC, Braun DK, Erickson JS, Berclaz PY, Banerjee S, Heffernan MP, Carlier H. Safety and efficacy of open-label subcutaneous ixekizumab treatment for 48 weeks in a phase II study in biologic-naive and TNF-IR patients with rheumatoid arthritis. J Rheumatol 2016; 43: 289-97. (Among 300 patients with rheumatoid arthritis treated with ixekizumab in a controlled trial [Genovese 2014] who were maintained on ixekizumab for 48 weeks in an open label extension study, clinical responses were maintained and adverse events included one instance of ALT elevations above 5 times ULN that resolved despite continuing therapy without dose adjustment). 26669919
Fragoulis GE, Siebert S, McInnes IB. Therapeutic targeting of IL-17 and IL-23 cytokines in immune-mediated diseases. Annu Rev Med 2016; 67: 337-53. (Review of the discovery and elucidation of the IL-17 and IL-23 cytokine pathways and their potential role as targets for therapy of immune mediated diseases). 26565676
Gordon KB, Blauvelt A, Papp KA, Langley RG, Luger T, Ohtsuki M, Reich K, et al.; UNCOVER-1 Study Group.; UNCOVER-2 Study Group.; UNCOVER-3 Study Group. Phase 3 trials of ixekizumab in moderate-to-severe plaque psoriasis. N Engl J Med 2016; 375: 345-56. (Among 3866 patients with plaque psoriasis in controlled trials of ixekizumab who were given extended therapy for at least 60 weeks, clinical responses were maintained in 80% of patients, while serious adverse events included inflammatory bowel disease in 11 and neutralizing antibody in 19 patients [1.7%], but no mention of ALT elevations or hepatotoxicity). 27299809
Ixekizumab (Taltz)--a second IL-17A inhibitor for psoriasis. Med Lett Drugs Ther 2016; 58 (1494): 59-60. (Concise review of the mechanism of action, clinical efficacy, safety and costs of ixekizumab shortly after its approval in the United States for plaque psoriasis; mentions common adverse effects, but does not mention ALT elevations or hepatotoxicity). 27148922
Saeki H, Nakagawa H, Nakajo K, Ishii T, Morisaki Y, Aoki T, Cameron GS, Osuntokun OO; Japanese Ixekizumab Study Group. Efficacy and safety of ixekizumab treatment for Japanese patients with moderate to severe plaque psoriasis, erythrodermic psoriasis and generalized pustular psoriasis: Results from a 52-week, open-label, phase 3 study (UNCOVER-J). J Dermatol 2017; 44: 355-62. (Among 92 Japanese patients with psoriasis treated with ixekizumab for 52 weeks, clinical responses occurred in 81% and adverse events in 89% including ALT elevations in 5 [6%]; no details provided, but there were no liver related serious adverse events). 27726163
Strober B, Leonardi C, Papp KA, Mrowietz U, Ohtsuki M, Bissonnette R, Ferris LK, et al. Short- and long-term safety outcomes with ixekizumab from 7 clinical trials in psoriasis: Etanercept comparisons and integrated data. J Am Acad Dermatol 2017; 76: 432-40 (Among 4209 patients with psoriasis enrolled in 7 clinical trials of ixekizumab and treated for 12-60 weeks, infections were more frequent with ixekizumab, but were mostly mild; no cases of active tuberculosis or invasive fungal infections occurred and no mention of ALT elevations or hepatoxicity). 27889292
Callis Duffin K, Bagel J, Bukhalo M, Mercado Clement IJ, Choi SL, Zhao F, Gill A, et al. Phase 3, open-label, randomized study of the pharmacokinetics, efficacy and safety of ixekizumab following subcutaneous administration using a prefilled syringe or an autoinjector in patients with moderate-to-severe plaque psoriasis (UNCOVER-A). J Eur Acad Dermatol Venereol 2017; 31: 107-13. (Among 204 patients with plaque psoriasis treated with ixekizumab using prefilled syringes vs autoinjectors, clinical response rates at 12 weeks were similar [89% vs 87%] as were adverse events [50% vs 45%]; no mention of ALT elevations or hepatotoxicity). 27500949
Mease PJ, van der Heijde D, Ritchlin CT, Okada M, Cuchacovich RS, Shuler CL, Lin CY, et al.; SPIRIT-P1 Study Group. Ixekizumab, an interleukin-17A specific monoclonal antibody, for the treatment of biologic-naïve patients with active psoriatic arthritis: results from the 24-week randomised, double-blind, placebo-controlled and active (adalimumab)-controlled period of the phase III trial SPIRIT-P1. Ann Rheum Dis 2017; 76: 79-87. (Among 417 patients with active psoriatic arthritis treated with adalimumab, placebo or ixekizumab [80 mg every 2 or 4 weeks] for 24 weeks, clinical response rates were highest with ixekizumab [60% vs 50% and 30%] as were adverse events rates [66% vs 64% vs 47%] including ALT elevations that occurred in 3-4% on ixekizumab vs none on placebo). 27553214

## OTHER REFERENCE LINKS

1. Recent References on Ixekizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ixekizumab/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2. Trials on Ixekizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ixekizumab)